# Aliskiren

## OVERVIEW

### Introduction

Aliskiren is a unique antihypertensive agent that acts by direct inhibition of renin and has only recently been introduced into clinical practice. Aliskiren has been linked to rare instances of serum aminotransferase elevations during therapy and rare cases of idiosyncratic, clinically apparent liver injury.

### Background

Aliskiren (al' is key' ren) is a direct inhibitor of renin and acts to inhibit its ability to convert angiotensinogen to angiotensin 1, an early step in the renin-angiotensin system pathway. By inhibiting renin and the subsequent production of angiotensin II and aldosterone release, aliskiren results in a decrease in peripheral vasoconstriction and increase in sodium excretion. Aliskiren is effective in lowering blood pressure and can be used alone or in combination with other antihypertensive medications, including other inhibitors of the renin-angiotensin system such as the angiotensin converting enzyme (ACE) inhibitors and the angiotensin receptor blockers (ARBs). In 2007, aliskiren became the first in the class of direct renin inhibitors to be approved for use in the United States. Aliskiren is available in under the brand name of Tekturna in tablets of 150 and 300 mg. Fixed combinations of aliskiren with hydrochlorthiazide (Tekturna HCT), valasartan (Valturna) and amlodipine (Amturnide) are also available. The typical initial dose of aliskiren in adults is 150 daily, which can be increased to 300 mg daily based upon effects and tolerance. Side effects are uncommon and usually mild; they include diarrhea, headaches, fatigue, dizziness and nasopharyngitis.

### Hepatotoxicity

Serum aminotransferase elevations during aliskiren therapy are uncommon and rates of such elevations have not been reported in the large clinical trials that demonstrated its efficacy in hypertension. An instance of serum aminotransferase elevation with jaundice was reported in the registration trials of aliskiren and several instances of marked serum enzyme elevations during therapy with few symptoms and without jaundice have been reported. In most instances, the pattern of enzyme elevation was distinctly hepatocellular and recovery was prompt once aliskiren was stopped. There have also been reports to the sponsor of severe hepatic reactions including hepatic failure and more recently a published case report of acute liver injury attributed to this agent. The latency to onset has ranged from 1 to 6 months and the pattern of injuryis typically cholestatic or mixed. Most cases have been mild to moderate in severity and marked by rapid recovery once aliskiren is stopped.

Likelihood score: C (probable cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of liver injury due to aliskiren is not known. Aliskiren is metabolized in the liver by the cytochrome P450 (CYP 3A4) system, but has little effect on drug metabolizing activity. Concurrent use of CYP 3A4 inhibitors such as cyclosporin or itraconazole can cause an increase in aliskiren levels.

### Outcome and Management

Severity ranges from asymptomatic elevations in serum aminotransferase levels to mildly symptomatic cholestatic hepatitis with or without jaundice. There are no convincing cases of fulminant hepatic failure, chronic hepatitis or vanishing bile duct syndrome attributable to aliskerin use in the published literature. Patients with aliskiren induced liver injury need not avoid other antiihypertensive agents.

Drug Class: Antihypertensive Agents

## CASE REPORTS SUBMITTED TO LIVERTOX

Clinical cases of drug-induced liver injury that have been submitted to LiverTox ("Submit a Case Report" (https://livertox.niddk.nih.gov/)) are available for review. Most of these reference cases are from the Drug-Induced Liver Injury Network, but others are from users of LiverTox who have submitted data from an actual clinical case. All cases have been reviewed and cleared of personal identifiers and a brief comment added by the LiverTox editors. Click on the following link to view the submitted case reports that have been made publically available.

[underlined: Submitted Cases on Aliskiren] (https://livertox.niddk.nih.gov/Home/ReferenceCases/aliskiren)

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Aliskiren – Tekturna®

DRUG CLASS

Antihypertensive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=aliskiren)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Aliskiren | 173334-57-1 | C30-H53-N3-O6 | Aliskiren Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 23 February 2016

Zimmerman HJ. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 655-6. (Expert review of hepatotoxicity published in 1999, before the availability of aliskiren).
De Marzio DH, Navarro VJ. Antihypertensives. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 522-6. (Review of liver injury due to antihypertensive agents; aliskiren is not discussed).
Hilal-Dandan R. Renin and Angiotensin. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 721-44. (Textbook of pharmacology and therapeutics).
Michel T, Hoffman BB. Therapy of myocardial ischemia and hypertension. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 745-88. (Textbook of pharmacology and therapeutics; aliskiren has a place as an add-on rather than a first line drug in treating hypertension).
Straessen JA, Li Y, Richart T. Oral renin inhibitors. Lancet 2006; 368: 1449-56. (Review of history of attempts to develop direct renin inhibitors and the pharmacology and mechanism of action of aliskiren; no discussion of side effects or hepatotoxicity). 17055947
Daugherty KK. Aliskiren. Am J Health Syst Pharm 2008; 65: 1323-32. (Review of pharmacology, pharmacokinetics, clinical efficacy and safety of aliskiren; most common side effects were headache, fatigue, dizziness and diarrhea [all <10%, and similar to rates with placebo]; rare side effects [<1%] were rash, gout, and renal stones, no mention of ALT elevations or hepatotoxicity). 18593678
Gradman AH, Schmieder RE, Lins RL, Nussberger J, Chiang Y, Bedigian MP. Aliskiren, a novel orally effective renin inhibitor, provides dose-dependent antihypertensive efficacy and placebo-like tolerability in hypertensive patients. Circulation 2005; 111: 1012-8. (Controlled trial of 8 weeks of aliskiren vs irbesartan vs placebo in 652 patients with hypertension; side effects were similar in the 3 groups and laboratory values remained normal “in the majority of patients”, but one patient on aliskiren stopped treatment because of elevations in AST and bilirubin). 15723979
Cheng JW. Aliskiren: renin inhibitor for hypertension management. Clin Ther 2008; 30: 31-47. (Systematic review of structure, pharmacology, mechanism of action, clinical efficacy and side effects of aliskiren; side effects evaluated in more than 6000 patients; most common included headache, dizziness, fatigue and gastrointestinal; no mention of ALT elevations or hepatotoxicity). 18343241
Luft FC, Weinberger MH. Antihypertensive therapy with aliskiren. Kidney Int 2008; 73: 679-83. (Review of pharmacology and mechanism of action of aliskiren). 8160962
Drugs for hypertension. Treat Guidel Med Lett 2009; 7: 1-10. (Brief overview of currently available drugs for hypertension with guidelines on their use with information on prices and toxicities; aliskiren is said to have similar side effects to the angiotensin receptor blockers, but also can cause gastrointestinal effects such as diarrhea). 19107095
Schmieder RE, Philipp T, Guerediaga J, Gorostidi M, Smith B, Weissbach N, Maboudian M, et al. Long-term antihypertensive efficacy and safety of the oral direct renin inhibitor aliskiren: a 12-month randomized, double-blind comparator trial with hydrochlorothiazide. Circulation 2009; 119: 417-25. (Controlled trial of aliskiren vs hydrochlorothiazide [HCTZ] vs placebo in 1124 patients with hypertension; adverse event rates were similar in the aliskiren and HCTZ groups and were generally mild and transient; no mention of ALT elevations or hepatotoxicity and no deaths attributed to drug therapy). 19139391
Kushiro T, Itakura H, Abo Y, Gotou H, Terao S, Keefe DL. Long-term safety, tolerability, and antihypertensive efficacy of aliskiren, an oral direct rennin inhibitor, in Japanese patients with hypertension. Hypertens Res 2009; 32: 169-75. (Open label study of 52 weeks of aliskiren in 345 patients with hypertension; side effects were mild and rarely required dose modification; no mention of ALT elevations or hepatotoxicity). 19262478
Angeli F, Reboldi G, Mazzotta G, Poltronieri C, Verdecchia P. Safety and efficacy of aliskiren in the treatment of hypertension: a systematic overview. Expert Opin Drug Saf 2012; 11: 659-70. (Aliskiren is well tolerated and side effects are "placebo-like", the only symptom more frequent with aliskiren being diarrhea [2.3%]; no discussion of ALT elevations or hepatotoxicity). 22724663
Parving HH, Brenner BM, McMurray JJ, de Zeeuw D, Haffner SM, Solomon SD, Chaturvedi N, et al.; ALTITUDE Investigators. Cardiorenal end points in a trial of aliskiren for type 2 diabetes. N Engl J Med 2012; 367: 2204-13. (Among 8561 patients with diabetes and either renal or cardiovascular disease, the addition of aliskiren to chronic therapy an ACE inhibitor or angiotensin receptor blocker was associated with higher rates of side effects and no decrease in cardiovascular complications; no mention of ALT elevations or hepatotoxicity). 23121378
Crepin S, Godet B, Carrier P, Villeneuve C, Merle L, Laroche ML. Probable drug-induced liver injury associated with aliskiren: case report and review of adverse event reports from pharmacovigilance databases. Am J Health Syst Pharm 2014; 71: 643-7. (61 year old woman was found to have elevations in serum enzymes one month after starting aliskiren [bilirubin 0.5 mg/dL, ALT 987 U/L, Alk P 466 U/L, GGT 820 U/L], with rapid improvement on stopping; review of various adverse event registries identified 272 reports of hepatic events, mostly serum enzyme elevations only, but at least 6 of "hepatic failure"). 24688038
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, one case was attributed to aliskiren; a 65 year old woman developed liver enzyme elevations with minimal symptoms 7 months after starting aliskiren [bilirubin 0.6 mg/dL, ALT 545 U/L, Alk P 239 U/L], resolving within 6 months of stopping). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Aliskiren: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Aliskiren/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Aliskiren: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Aliskiren)